# Ampicillin-Sulbactam

## OVERVIEW

The combination of ampicillin and sulbactam sodium combines a third generation aminopenicillin and a beta-lactamase inhibitor and is used to treat serious bacterial infections due to susceptible organisms. Given parenterally, ampicillin and sulbactam can cause mild transient aminotransferase elevations and has been linked to very rare instances of acute liver injury.

### Background

The combination of ampicillin (am" pi sil' in) with sulbactam (sul bak' tam) is a parenterally administered, broad spectrum, potent antibiotic which combines a third generation, aminopenicillin with a beta lactamase inhibitor. This combination was approved for use in the United States in 1986. Current indications are for moderate-to-severe skin and skin structure, intra-abdominal and gynecological infections due to susceptible gram-positive and gram-negative bacteria, including beta-lactamase-producing strains of Staphylococcus aureus, Escherichia coli, Klebsiella pneumoniae, Proteus mirabilis, Bacteroides species, Enterobacter species, Neisseria meningitidis and gonorrhoeae, Moraxella catarrhalis and Acinetobacter calcoaceticus. The combination of ampicillin and sulbactam is available in a parenteral form generically and previously under the name Unasyn. The typical dose is 1.5 to 3 grams intramuscularly or intravenously every 6 hours for 7 to 14 days. Common side effects include diarrhea, nausea and vomiting, fatigue, headache, local reactions and rash. Rare but potentially serious adverse events include hypersensitivity reactions, anaphylaxis, severe skin rash, Stevens Johnson syndrome, C. difficile diarrhea, neutropenia, aplastic anemia and thrombocytopenic purpura.

### Hepatotoxicity

Parenteral therapy with ampicillin-sulbactam has been reported to cause transient low level elevations in serum aminotransferase levels in 5% to 10% of patients, but these resolve rapidly once the therapy is stopped, and similar rates of enzyme elevations are found with comparable agents. Clinically apparent liver injury due to ampicillin-sulbactam is rare; instances have been published in individual case reports only and the drug is rarely mentioned in large case series or prospective databases on drug-induced liver injury. The reactions have been attributed to ampicillin rather than sulbactam and resemble the hepatic injury that occurs with ampicillin or amoxicillin alone. The liver injury is typically abrupt with short latency period and cholestatic features. The onset of hepatic injury may be accompanied by eosinophilia, arthralgias and skin rash, and occasionally with toxic epidermal necrolysis or Stevens-Johnson syndrome. The injury is usually self-limited in course, but fatal instances have been reported to the sponsor.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with ampicillin use is probably hypersensitivity or allergy. Recurrence of hepatic injury has been reported after ampicillin induced liver injury with reexposure.

### Outcome and Management

In the few cases that have been described, most patients have recovered although recovery has been slow in some cholestatic instances (2 to 6 months) and may be followed by persistent elevations in serum alkaline phosphatase. Acute liver failure and vanishing bile duct syndrome have been reported with aminopenicillin induced liver injury, but not specifically with ampicillin-sulbactam. Corticosteroids have often been used to treat the allergic manifestations of penicillin related immunoallergic hepatitis; while corticosteroid therapy may improve fever and rash promptly, their efficacy in ameliorating the accompanying liver disease has not been shown. Instances of recurrence of liver injury with reexposure to aminopenicillins and recurrence with exposure to cephalosporins have been reported. Patients with aminopenicillin induced hepatitis should avoid reexposure to other penicillins and should take cephalosporins with caution.

Drug Class: Antiinfective Agents, Aminopenicillins

Other Drugs in the Subclass, Aminopenicillins: Amoxicillin, Amoxicillin-Clavulanate, Ampicillin, Bacampicillin, Pivampicillin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ampicillin-Sulbactam – Generic, Unasyn®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ampicillin%20and%20Sulbactam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ampicillin-Sulbactam | 94935-63-4 | C16-H19-N3-O4.S C8-H11-N-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2026

Zimmerman HJ. Penicillins. In, Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams and Wilkins, 1999. p. 595-6. (Expert review of penicillins and liver injury published in 1999; the penicillins commonly lead to hypersensitivity reactions but rarely to liver injury).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that penicillins rarely cause liver injury and both hepatocellular and cholestatic patterns of injury have been described).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
McArthur JE, Dyment PG. Stevens-Johnson syndrome with hepatitis following therapy with ampicillin and cephalexin. N Z Med J 1975; 81: 390-2. (Stevens-Johnson syndrome developed in a 9 month old child given ampicillin [rash] and cephalexin, with subsequent hepatocellular injury [bilirubin 13 mg/dL], resolving with prednisone therapy). 1057088
Lees L, Milson JA, Knirsch AK, Greenhalgh K. Sulbactam plus ampicillin: interim review of efficacy and safety for therapeutic and prophylactic use. Rev Infect Dis 1986; 8 (Suppl 5): S644-S650. (Review of 45 studies of ampicillin-sulbactam in 899 patients found successful outcome in 92%; ALT elevations in 6.9%, AST in 6.2%, but all resolved with stopping and similar rates were reported with use of comparative agents). 3026019
Galante D, Esposito S, Barba D, Ruffilli MP. Clinical efficacy and safety of sulbactam/ampicillin in patients suffering from chronic liver disease. J Antimicrob Chemother 1987; 19: 527-32. (41 patients with advanced liver disease were given sulbactam/ampicillin; there was no worsening of liver disease or enzyme elevations attributed to medication). 3034850
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports in Denmark from 1978 to 1987; no mention of aminopenicillins). 1506809
Köklü S, Köksal AS, Asil M, Kiyici H, Coban S, Arhan M. Probable sulbactam/ampicillin-associated prolonged cholestasis. Ann Pharmacother 2004; 38: 2055-8. (74 year old developed cholestatic hepatitis arising 1 week after 7 day course of ampicillin-sulbactam with prolonged jaundice [bilirubin 31 mg/dL, ALT 33 U/L, Alk P 519 U/L], resolving after 7 months, except mild GGT elevations). 15494387
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure; one case was attributed to amoxicillin-clavulanate, but none to penicillin, ampicillin, or amoxicillin alone). 15390328
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 3 [1%] were attributed to the combination of amoxicillin and clavulanate, but none were attributed to ampicillin, ampicillin-sulbactam, or amoxicillin alone]. 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 66 due to antimicrobial agents, including two attributed to amoxicillin but none to ampicillin; no details given). 20949552
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, amoxicillin-clavulanate accounted for 38 cases [0.4%] for an adjusted odds ratio of 1.7, whereas neither amoxicillin alone or ampicillin were listed among the 41 most common causes [linked to at least 30 cases]). 21039766
Köksal AS, Yildiz H, Onder O, Avci S, Kayaåetin E. Sulbactam/ampicillin associated hepatocellular type liver injury. Acta Gastroenterol Belg 2012; 75: 66-7. (47 year old woman developed jaundice 8 days after a 4 day course of ampicillin-sulbactam [bilirubin 18.9 mg/dL, ALT 1344 U/L, Alk P 208 U/L], resolving within 10 weeks of stopping). 22567755
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, the most commonly implicated agent being amoxicillin with clavulanate [15 cases]; none were attributed to amoxicillin alone or ampicillin). 23419359
Sistanizad M, Peterson GM. Drug-induced liver injury in the Australian setting. J Clin Pharm Ther 2013; 38: 115-20. (Among 17 cases of suspected drug induced liver injury seen at a single referral hospital in Tasmania over a 12 month period, 11 were due to antibiotics including flucloxacillin in 4, amoxicillin in 2, amoxicillin-clavulanate in 2, and rifampin, moxifloxacin and ciprofloxacin in 1 each; none were attributed to ampicillin). 23350857
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Giaquinto C, Picelli G, Oteri A, et al. Idiopathic acute liver injury in paediatric outpatients: incidence and signal detection in two European countries. Drug Saf 2013; 36: 1007-16. (Analysis of 3 electronic healthcare databases from Italy and the Netherlands from 2000-2008 identified 785 cases of unexplained acute liver injury in children, linked to 110 possible medications, with increased adjusted relative risk [RR] of recent exposure to amoxicillin-clavulanate [RR=18.6] and amoxicillin [RR=7.5]; no mention of ampicillin). 23591830
Kaye JA, Castellsague J, Bui CL, Calingaert B, McQuay LJ, Riera-Guardia N, Saltus CW, et al. Risk of acute liver injury associated with the use of moxifloxacin and other oral antimicrobials: a retrospective, population-based cohort study. Pharmacotherapy 2014; 34: 336-49. (In a US healthcare database with 1.3 million antimicrobial users, there were 607 cases of liver injury and 11 cases of liver failure, the highest relative risk for current single use being 3.2 for levofloxacin, 2.5 for amoxicillin-clavulanate, 2.5 for doxycycline, 2.3 for moxifloxacin and 2.3 for amoxicillin; no information provided on ampicillin). 24865821
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin-clavulanate, but none to ampicillin or 2nd or 4th generation penicillins). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to 1st, three to 2nd [all due to oxacillin], 97 to 3rd [91 to amoxicillin-clavulanate, and 6 to amoxicillin alone] and five to 4th generation penicillins [all 5 to piperacillin[-tazobactam]; none were attributed to ampicillin or ampicillin-sulbactam). 25754159
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol 2015; 135: 253-9. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses, but they did not apply to cephalosporin cases). 25224099
Nicoletti P, Aithal GP, Björnsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al.; International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology 2017; 152: 1078-89. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine). 28043905
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol 2015; 136: 1288-94.e1. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided). 25981739
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Björnsson ES, Chalasani N, Fontana RJ, et al.; Drug-Induced Liver Injury Network (DILIN) investigators; International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology 2019; 156: 1707-16.e2. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions). 30664875
Lim R, Choudry H, Conner K, Karnsakul W. A challenge for diagnosing acute liver injury with concomitant/sequential exposure to multiple drugs: can causality assessment scales be utilized to identify the offending drug? Case Rep Pediatr. 2014;2014:156389.. (12 year old boy with lymphadenitis was treated with amoxicillin and then ceftriaxone and vancomycin followed by ampicillin-sulbactam and then clindamycin and shortly thereafter developed fever and dark urine [bilirubin 3.0 rising to 13.5 mg/dL, ALT 406 U/L, Alk P 404 U/L, INR 1.10], the cause being difficult to assign because of the 5 different antibiotics used, any of which might be the cause). 25506455
Alhaddad O, Elsabaawy M, Abdelsameea E, Abdallah A, Shabaan A, Ehsan N, Elrefaey A, et al. Presentations, causes and outcomes of drug-induced liver injury in Egypt. Sci Rep. 2020;10:5124.. (Among 75 patients with drug-induced liver injury seen at an Egyptian referral center between 2015 and 2016, 56 [71%] were in patients with chronic hepatitis C, and the most common causes were diclofenac [41%], amoxicillin-clavulanate [19%], halothane [11%], ibuprofen [5%], and khat [4%]; none were due to ampicillin, ampicillin-sulbactam or other aminopenicillins). 32198411
Suzuki T, Sugiyama E, Nozawa K, Tajima M, Takahashi K, Yoshii M, Suzuki H, et al. Effects of dosing frequency on the clinical efficacy of ampicillin/sulbactam in Japanese elderly patients with pneumonia: A single-center retrospective observational study. Pharmacol Res Perspect. 2021;9:e00746.. (Among 106 patients 70 years or older with pneumonia treated with intravenous ampicillin-sulbactam in doses of 6 gm given either 2 vs 4 times daily, the clinical response rates were 36% vs 56% while adverse event rates were similar, ALT elevations arising in 16% of both groups which were above 3 times ULN in 1 vs 2 participants and with no episodes of clinically apparent liver injury). 33764686
Fowler C, Namtu K. Ampicillin-sulbactam-induced liver injury in a pediatric patient. J Pediatr Pharmacol Ther. 2023;28:747-751.. (12 year old boy with seizures, developmental delay, and recurrent aspiration pneumonia developed respiratory failure and pleural effusion and was treated with ampicillin-sulbactam [2 gm 4 times daily] and developed worsening liver tests which peaked at day 5 [bilirubin direct 0.8, total 1.2 mg/dL, ALT 1328 U/L, AST 2171 U/L, INR 2.1] which began to resolve with stopping ampicillin-sulbactam, considered the cause although ischemic hepatitis was also likely). 38094676
Gu S, Rajendiran G, Forest K, Tran TC, Denny JC, Larson EA, Wilke RA. Drug-induced liver injury with commonly used antibiotics in the All of Us Research Program. Clin Pharmacol Ther. 2023;114:404-412.. (Among patients enrolled in a prospective study of genetics and health who had been exposed to various drugs, electronic medical records identified 30 attributable to amoxicillin-clavulanate, 22 to amoxicillin, but drugs with fewer than 20 cases, such as ampicillin-sulbactam, were not mentioned). 37150941
Medina-Cáliz I, Sanabria-Cabrera J, Villanueva-Paz M, Aukštikalnė L, Stephens C, Robles-Díaz M, Pinazo-Bandera JM, et al. Characterization of drug-induced liver injury associated with drug reaction with eosinophilia and systemic symptoms in two prospective DILI registries. Arch Toxicol. 2024;98:303-325.. (Among 1437 patients enrolled in the Spanish and Latin American registries of drug-induced liver injury, 53 [3.7%] developed DRESS syndrome, the most common causes were carbamazepine [13%], anti-tuberculous agents [13%], amoxicillin-clavulanate [11%], allopurinol [8%], and lamotrigine [8%]: no case due to ampicillin or ampicillin-sulbactam developed DRESS). 38051367
Ooi H, Asai Y, Sato Y. Risk evaluation of ampicillin/sulbactam-induced liver injury based on albumin-bilirubin score. J Infect Chemother. 2023;29:900-904.. (Among 380 patients treated with ampicillin-sulbactam at a single Japanese referral center, 36 [9.5%] developed ALT or Alk P elevations above twice ULN during or shortly after therapy, no mention of symptoms or concurrent bilirubin levels). 37301371
Pinazo-Bandera JM, Niu H, Alvarez-Alvarez I, Medina-Cáliz I, Del Campo-Herrera E, Ortega-Alonso A, Robles-Díaz M, et al. Rechallenge in idiosyncratic drug-induced liver injury: An analysis of cases in two large prospective registries according to existing definitions. Pharmacol Res. 2024;203:107183.. (Among 1418 patients enrolled in the Spanish and Latin American registries of drug-induced liver injury, 58 had a positive rechallenge response including 10 due to amoxicillin-clavulanate and 1 due to amoxicillin, but no mention of ampicillin or other penicillins). 38631619
Ishikawa K, Kobayashi D, Mori N. Adverse events comparison of double beta-lactam combinations for bloodstream infections: ampicillin plus ceftriaxone and ampicillin/cloxacillin. Antibiotics (Basel). 2024;13:696.. (Analysis of adverse events in 277 patients hospitalized with infections receiving ampicillin-sulbactam alone vs 57 receiving it combined with a cephalosporin vs 43 receiving it combined with cloxacillin revealed ALT elevations above 3 times ULN in 9.5% vs 19.3% vs 16.3% which were above 5 times ULN in 3.6% vs 8.8% vs 9.3%; no mention of concurrent bilirubin elevations or clinically apparent liver injury). 39199996
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 58 [14%] were attributed to amoxicillin-clavulanate, 2 [0.5%] to amoxicillin alone, 1 to ampicillin, but none to ampicillin-sulbactam; clinical details not given). 38992407
Hamao N, Ito I, Konishi S, Tanabe N, Oi I, Yasutomo Y, Kadowaki S, et al. Incidence of and risk factors for side effects associated with antibiotic treatment for pneumonia. J Infect Chemother. 2025;31:102789.. (Among 1028 Japanese patients hospitalized for treatment of pneumonia with various parenteral antibiotics and monitored for adverse events, elevations in liver enzymes [2 times ULN and higher] arose in 4.5% overall, greatest with meropenem [8.3%: 97 cases], only 1.7% with ampicillin-sulbactam [362 cases], and 0% with piperacillin-tazobactam [111 cases]). 40784408
Shefa D, Shiari A, Antic M, Hatharaliyadda BP, Gomez JV, Ladin D, Dumic I. Severe necrotizing community-acquired pneumonia and bilateral empyema in an immunocompetent patient due to Fusobacterium necrophorum. Case Rep Pulmonol. 2026;2026:5505327. (22 year old college student with F. necrophorum empyema developed a rise in ALT [48 to 170 U/L], with no change in bilirubin or Alk P, 5 days after starting piperacillin-tazobactam, vancomycin, and doxycycline and was switched to ampicillin-sulbactam while vancomycin and doxycycline were discontinued based upon sensitivity testing of the bacterial isolate with no subsequent worsening, although the ALT abnormalities persisted). 41541042

## OTHER REFERENCE LINKS

1. Recent References on Ampicillin-Sulbactam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ampicillin/AE+AND+sulbactam/AE+AND+liver)

2. Trials on Ampicillin-Sulbactam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ampicillin%20and%20Sulbactam)